# Autoimmune Hepatitis

Description. Drug induced liver injury with autoimmune features (also called drug induced autoimmune hepatitis) is marked by acute or chronic liver injury accompanied by development of autoantibodies, a hepatocellular pattern of serum enzyme elevations, and liver biopsy features suggestive of idiopathic autoimmune hepatitis. Drug induced autoimmune hepatitis resembles idiopathic autoimmune hepatitis, but typically resolves completely once the medication is withdrawn, although recovery may be slow and lead to a limited course of corticosteroid therapy.

Latency to Onset. The time to onset of drug induced autoimmune hepatitis is usually more than 6 months and can be up to several years after initiation of therapy. In some situations, onset is more rapid and the clinical phenotype resembles acute hepatitis, but onset with appearance of autoantibodies is rare before 2 months.

Symptoms. The onset of drug induced autoimmune hepatitis is typically insidious, sometimes with extrahepatic manifestations such as rash or joint pains that precede symptoms of hepatic injury (fatigue, nausea, poor appetite). Jaundice arises late and may follow several months of nonspecific symptoms.

Serum Enzyme Elevations. Autoimmune hepatitis due to medications is typically manifested by moderate serum aminotransferase elevations (200 to 800 IU/L: 5 to 20 times ULN) with minimal increase in alkaline phosphatase levels (<230 U/L: <2 times ULN), suggestive of chronic rather than acute hepatitis. Serum autoantibodies are usually (but not invariably) present, including antinuclear (ANA), smooth muscle antibody (SMA) or antibody to liver-kidney microsomes (anti-LKM). Immunoglobulin levels and total globulins are often but not always raised. Medications that cause autoimmune hepatitis associated with chronic hepatitis can often also cause an acute viral hepatitis-like syndrome (minocycline, nitrofurantoin, methyldopa, hydralazine) and these two phenotypes may overlap. Recovery after stopping the medication in autoimmune hepatitis may be delayed and lead to use of corticosteroids, which typically results in prompt improvement. Autoantibody titers and immunoglobulin levels also decrease with recovery, but low levels of autoantibodies may persist long term. In most instances, drug induced autoimmune hepatitis ultimately resolves once the medication is stopped, although this may take 6 months or more; in some cases, however, particularly with biologic response modifiers (interferons, tumor necrosis factor antagonists), the autoimmune hepatitis appears to have been triggered rather than caused by the drug and can be self sustaining and require long term immunosuppressive therapy.

Drugs. Medications that typically cause autoimmune hepatitis include minocycline, nitrofurantoin, hydralazine, methyldopa, statins, fenofibrate, alpha and beta interferon, infliximab and etanercept. Individual case reports of an autoimmune hepatitis-like syndrome attributed to medications have implicated many other agents, including nonsteroidal antiinflammatory agents, azathioprine, and herbals. In addition, some medications induce autoantibodies even in the absence of hepatic injury (isoniazid, procainamide) and their presence during liver injury may be coincidental.

Criteria for Definition. There are no established diagnostic criteria for drug induced autoimmune hepatitis; however, based upon similarity to idiopathic autoimmune hepatitis the following are important elements in the diagnosis:

1 Time to onset of 2 months or more
2 Rash, arthralgias or extrahepatic manifestations
3 Hepatocellular pattern of serum enzyme elevations (R >5 at onset)
4 Presence of an autoantibody in titers of 1:80 or greater (ANA, SMA or anti-LKM)
5 Raised immunoglobulin (IgG >1800 mg/dL) or total globulin levels (>3.0 grams/dL)
6 Exposure to an agent that is typically associated with drug induced autoimmune hepatitis: nitrofurantoin, methyldopa, minocycline, hydralazine, alpha interferon, beta interferon, cholesterol lowering agents
7 Liver biopsy showing features of chronic hepatitis with interface hepatitis and prominence of plasma cells
8 Prompt response to corticosteroid therapy (decrease in ALT levels by half within 2 weeks)
9 Ultimate resolution upon stopping the medication (and corticosteroid therapy), although resolution may be slow and may call for corticosteroid therapy for several months.

Proof that a drug is the cause of an autoimmune hepatitis-like syndrome is sometimes difficult, particularly if the medication is not a common cause. Most diagnostic is a resolution of the syndrome with withdrawal of the agent. Improvements, however, often take several weeks to begin and the presence of features of autoimmunity often prompt treatment with corticosteroids, the usual therapy of idiopathic autoimmune hepatitis. While controlled trials of corticosteroid therapy have not been conducted in drug induced autoimmune hepatitis, case reports and small case series suggest that corticosteroids induce a prompt improvement in serum bilirubin and aminotransferase elevations. In this regard as well, drug induced resembles idiopathic autoimmune hepatitis.

Distinction between drug induced and idiopathic autoimmune hepatitis can also be made if corticosteroids can be withdrawn without a relapse in disease. Relapse upon withdrawal of immunosuppression is common with idiopathic but atypical of drug induced autoimmune hepatitis (at least if the course of corticosteroids was adequate). Also, typical of drug induced injury is disappearance of the autoantibodies with resolution. Spontaneous improvements can occur in idiopathic autoimmune hepatitis, but relapse is ultimately common, although sometimes months or years later. Once resolved, relapse of an autoimmune hepatitis initially triggered by a drug is unusual unless the drug is restarted.

Clinical Features and Course. Drug induced autoimmune hepatitis typically presents with the insidious onset of fatigue, weakness, nausea, poor appetite, right upper quadrant discomfort and jaundice or pruritus. The pattern of enzyme elevations is predominantly hepatocellular with prominent elevations in serum aminotransferase and modest increases in alkaline phosphatase levels. The severity of drug induced autoimmune hepatitis ranges widely from mild serum enzyme elevations with few if any symptoms, to symptomatic but anicteric hepatitis, to an acute or chronic hepatitis, to acute liver failure. If severe and prolonged injury occurs, evidence of hepatocellular dysfunction can arise including low serum albumin and prolongation of prothrombin time, and the injury can result in cirrhosis and end stage liver disease. In rare instances, the injury is acute and severe, leading rapidly to acute liver failure and death or need for liver transplantation.

Most characteristic of drug induced autoimmune hepatitis are the autoimmune features, including increases in serum immunoglobulins (particularly IgG) and autoantibodies. The most typical autoantibodies are directed at nuclear (ANA), smooth muscle (SMA) and liver-kidney microsomal antigens (anti-LKM). The pattern and specificity of these autoantibodies may provide a clue to the pathogenesis of the apparent autoimmune process induced by the medication, occasionally having specificity for a metabolic intermediate or drug-protein adduct such as antibody to altered P450 enzymes or anti-CYP 2D6. However, by far the most common autoantibodies found are nonspecific ANA reactivity or SMA with the typical anti-actin reactivity.

Drug induced autoimmune hepatitis typically arises 2 months to several years after starting the implicated medication and the clinical pattern of disease is more like chronic than acute liver injury. Patients may have extrahepatic manifestations of autoimmunity as well, such as arthralgias and skin rash or even other major organ involvement such as pneumonitis, nephritis or cerebritis. A history of other autoimmune diseases may be present but is not typical. Liver biopsy, if performed, usually shows elements that are typical of autoimmune hepatitis such as interface hepatitis with a lymphocytic or lymphoplasmocytic infiltrate and hepatic rosette formation. There may be variable degrees of fibrosis. In some instances, advanced fibrosis or even cirrhosis is present at the time of diagnosis, particularly if diagnosis and discontinuation of the medication is delayed.

Many of the agents that can induce autoimmune hepatitis can also induce other autoimmune conditions or symptoms such as a lupus-like syndrome (minocycline), pneumonitis (nitrofurantoin), hemolytic anemia (methyldopa) and acute thyroiditis (interferon alfa). Indeed, in these conditions there may be minor serum aminotransferase elevations indicative of a mild component of hepatic injury.

The important differential diagnosis for drug induced autoimmune hepatitis is, of course, spontaneous or idiopathic autoimmune hepatitis, a disease that can have spontaneous remissions and relapses, but that is typically severe and progressive without adequate immunosuppressive therapy. Some cases of drug induced autoimmune hepatitis do not resolve completely upon withdrawal of the medication, and some require long term immunosuppressive therapy and have had relapses (some severe) when corticosteroids were stopped. In these instances, it is not clear whether the autoimmune hepatitis-like syndrome was actually caused by the medication or was a co-incidence, arising spontaneously in a patient being treated long term with a common medication. An intermediate hypothesis is also possible, that the medication triggered the onset of autoimmune hepatitis in a susceptible patient that may have ultimately developed the disease, even without the medication. Often, this last possibility cannot be excluded. Spontaneous, idiopathic autoimmune hepatitis obviously has triggering factors for its onset and a medication or liver injury may be such a trigger. These issues call for careful clinical investigation of cases of autoimmune hepatitis associated with medications for genetic and environmental factors that might reveal the cause of this important syndrome.

Mechanism of Injury. The pathogenesis of autoimmune hepatitis due to medications is not clear. However, it is likely that hepatocytes, owing to their ability to metabolize drugs, can form drug-protein adducts which may be immunogenic. These newly formed antigens may, in turn, incite CD4+ and CD8+ cytotoxic lymphocyte and natural killer cell proliferative responses. The drug metabolizing enzymes (P450; CYP) are likely targets for neoantigen formation. Additionally, drugs may interact with T cell receptors to induce, and thus induce an immune response without forming cellular protein adducts.

There appears to be a genetic predisposition to autoimmune hepatitis from medications, and this may be the same genetic predisposition as for idiopathic autoimmune hepatitis. Indeed, in some instances, the hepatic injury from a medication appears to trigger autoimmune hepatitis and medications may be one of the environmental features that underlie the onset of this syndrome in susceptible patients. Genetic testing has shown that autoimmune hepatitis is closely linked to HLA types, in particular the extended haplotype of A3, B8, Dr3 and DrB03*0301 in Caucasians and northern Europeans with autoimmune hepatitis. This haplotype may also predispose to drug induced autoimmune hepatitis, although this has not been well defined.

Management. The most important element in management of drug induced autoimmune hepatitis is to recognize the possible role of the medication and discontinue it promptly. An adequate clinical and laboratory evaluation to assess the severity and characteristics of the injury is also important, as is testing for other possible causes. Liver biopsy is not necessary for diagnosis, but can be helpful and will provide information on the severity of the injury and the presence of any fibrosis.

Active therapy for autoimmune hepatitis using corticosteroids is often used in cases where a medication is thought to be the cause, although without controlled medical evidence for efficacy. Nevertheless, corticosteroid therapy is appropriate if recovery does not start within 1 to 2 weeks of stopping the implicated agent or if there is any evidence of hepatic failure, such as prolongation of the prothrombin time, deepening jaundice, hepatic encephalopathy, serum hypoalbuminemia with edema or ascites. An appropriate regimen would be prednisone (or its equivalent) in doses of 20 to 60 mg daily, decreasing the dose rapidly upon evidence of improvement with the goal to discontinue therapy completely within 3 to 6 months. High dose corticosteroid therapy can have significant and even permanent side effects, so that use of lower initial doses (20 to 30 mg daily) is appropriate for cases without signs of hepatic failure. An important element in using corticosteroids is careful follow up for at least six months after they have been discontinued to document full recovery and the absence of relapse, which can be severe and even fatal in patients with spontaneous autoimmune hepatitis in whom corticosteroids are stopped early.

## Representative Cases

### Case 1. Chronic hepatitis-like syndrome caused by long term methyldopa therapy.

[DILIN Case: 104-0034]

A 25 year old woman developed signs and symptoms of chronic liver disease after 8 months of therapy with methyldopa. Methyldopa had been started in a dose of 250 mg twice daily during a pregnancy, but was then continued after she had a Caesarian section 3 months later. After being on methyldopa for 8 months, she had the insidious onset of nausea, dark urine, itching and jaundice. She was admitted to a local hospital and laboratory testing showed an ALT of 1292 U/L and bilirubin of 7.3 mg/dL. Tests for hepatitis A, B and C were negative. Both smooth muscle and antinuclear antibody were negative. CT scans and ultrasound of the liver were normal. A liver biopsy showed changes typical of chronic active hepatitis. Methyldopa was stopped, and she was placed on prednisone. Serum aminotransferase levels slowly improved. Six months later prednisone was stopped and, in follow up, her liver tests remained normal.

#### Key Points

Medication: | Methyldopa
Pattern: | Hepatocellular (R=21)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 8 months
Recovery: | Complete after 6 month course of prednisone
Other medications: | Triamterene

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Methyldopa Started During Pregnancy
8 months | 0 | 1292 | 126 | 10.3 | Methyldopa stopped
| 1 week | 1053 | 101 | 19.3
| 2 weeks | 1140 | 156 | 24.9 | Prednisone started
9 months | 4 weeks | 362 | 169 | 11.9
| 6 weeks | 88 | 102 | 3.0
10 months | 8 weeks | 64 | 113 | 2.0
11 months | 3 months | 80 | 61 | 1.0 | Prednisone tapered
12 months | 4 months | 45 | 74 | 1.0
14 months | 6 months | 29 | 69 | 0.5 | Prednisone stopped
20 months | 12 months | 19 | 83 | 1.0
Normal Values | | <60 | <126 | <1.2

### Comment

This case represents a moderately severe example of autoimmune chronic hepatitis induced by methyldopa. Atypical was the lack of autoantibodies, but the clinical presentation, liver biopsy findings and response to corticosteroids provides convincing evidence for an autoimmune like reaction. The use of prednisone was justified based upon height of the bilirubin and ALT elevation. Importantly, once jaundice had resolved, the prednisone was withdrawn gradually, and in follow up, this patient was asymptomatic and had normal liver tests.

### Case 2. Severe acute hepatitis with autoimmune features caused by minocycline.

(DILIN Case: 104-0061)

A 21 year old man was started on minocycline for acne and two months later developed fatigue, dark urine and weight loss and stopped therapy on his own. A week later he was admitted to the hospital because of jaundice. He denied a previous history of liver disease or risk factors for viral hepatitis. He drank alcohol rarely. Serum bilirubin was elevated as were serum aminotransferase levels. Tests for hepatitis A, B, and C and for infectious mononucleosis were negative. Autoantibody testing showed a positive antinuclear antibody (1:1280), but negative tests for smooth muscle and liver-kidney microsomal antibodies. A liver biopsy was done which showed changes suggestive of autoimmune hepatitis with marked activity. He was started on prednisone and rapidly improved. Therapy was gradually reduced and then discontinued several months later without relapse of symptoms or recurrence of laboratory abnormalities.

#### Key Points

Medication: | Minocycline (100 mg daily for 9 weeks)
Pattern: | Hepatocellular (R=6.3)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 8 weeks
Recovery: | 2 months on prednisone
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
10 weeks | 1 week | 1343 | 783 | 5.7
11 weeks | 2 weeks | 1649 | 638 | 4.8 | Liver biopsy
Prednisone (60 mg daily) started
14 weeks | 5 weeks | 83 | 145 | 1.1
Normal Values | | <35 | <130 | <1.2

#### Comment

Minocycline can cause either an acute or a chronic hepatitis, but both are characterized by a hepatocellular pattern of serum enzyme elevations, the presence of autoantibodies and a liver biopsy showing changes typical of autoimmune hepatitis. Spontaneous recovery with stopping minocycline is the rule, but recovery can be prolonged, and prednisone therapy may speed the process. Whether prednisone actually improves ultimate outcome has not been proven. Nevertheless, both drug induced and spontaneous autoimmune hepatitis can be severe and even fatal, and prednisone therapy may provide rapid relief. Most important, however, is to limit the dose and duration of therapy, carefully monitoring patients after stopping for evidence of recurrence.

### Case 3. Severe autoimmune chronic hepatitis due to nitrofurantoin.

(DILIN Case: 101-0023)

An 84 year old woman was treated with nitrofurantoin 50 mg once daily for seven months. Because of recurrence of urinary tract infections, it was restarted one year later. After another 14 months of taking nitrofurantoin, she was found to have jaundice and peripheral edema. She was hospitalized for investigation. Serum aminotransferase, alkaline phosphatase, and bilirubin levels were elevated (Table). MRI suggested an infiltrating tumor in the liver, but endoscopic retrograde cholangiopancreatography was unrevealing and biopsy of the mass showed no evidence of tumor, but rather chronic inflammation and submassive hepatic necrosis. Tests for hepatitis A, B and C were negative. Antinuclear antibody and smooth muscle antibody titers were strongly positive. Symptoms of abnormal liver tests improved slowly after nitrofurantoin was stopped. At follow up 7 months later, the patient was asymptomatic, and liver enzyme levels were in reference range.

#### Key Points

Medication: | Nitrofurantoin
Pattern: | Chronic hepatitis, cholestatic pattern of enzymes (R=1.7)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 3 years after starting (intermittent therapy)
Recovery: | Protracted but complete
Other medications: | Losartan, warfarin, atorvastatin, diltiazem

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | Nitrofurantoin started
8 months | | Nitrofurantoin stopped
Pre-restarting | | 16
Nitrofurantoin restarted
7 months | | 52
9 months | | 115
12 months | | 190 | 175 | 1.5
13 months | | 197 | 359 | 3.8 | Edema
14 months | 0 | 307 | 503 | 5.0 | Nitrofurantoin stopped
15 months | 1 month | 89 | 301 | 5.8 | ANA 1:320
17 months | 3 months | 45 | 145 | 1.1
21 months | 7 months | 39 | | 0.9
Normal Values | | <42 | <130 | <1.2

#### Comment

This elderly lady presented with a clinical picture suggestive of liver cancer after more than a year of intermittent therapy with nitrofurantoin. A liver biopsy demonstrated a histologic picture of severe chronic active hepatitis. Autoimmune markers were present. The resolution of the injury after withdrawal of drug supports the diagnosis of a drug induced chronic hepatitis with autoimmune features.

### Case 4. Induction of autoimmune hepatitis by a course of peginterferon and ribavirin for chronic hepatitis C.

[NIH patient # G40]

A 52 year old woman with chronic hepatitis C developed sudden worsening of disease and jaundice 4 weeks after starting peginterferon therapy. She was known to have chronic hepatitis C for 12 years when she was found to have elevations in serum aminotransferase levels and antibody to hepatitis C in serum. She was largely asymptomatic and had no other medical problems. The source of hepatitis C was believed to be blood transfusions after Caesarian section 25 years previously. She had mild chronic hepatitis on liver biopsy and portal fibrosis (2+ fibrosis on a scale of 0 to 6+). HCV RNA levels ranged from 1 to 2 million IU/mL and genotype was 1b. She was started on peginterferon alfa-2a in a dose of 180 µg weekly and ribavirin (1200 mg daily) was added 4 weeks later. With therapy, her serum levels of HCV RNA fell rapidly (Table). Serum aminotransferase levels, however, started to rise and were above 1000 U/L by week four. By week five she was jaundiced and both peginterferon and ribavirin were stopped. Serum ANA was negative but SMA was weakly positive (1:40) and anti-LKM was present. IgM anti-HAV, anti-HBc and anti-HDV were negative. Ultrasound showed no evidence of biliary obstruction. Immunoglobin levels were elevated before therapy and had risen further (IgG 2130 to 2910 mg/dL). Jaundice worsened for a week and prednisone (20 mg daily) was started, whereupon both bilirubin and aminotransferase levels began to improve. Once ALT levels had returned to baseline, prednisone was gradually decreased and then stopped. However, serum ALT and immunoglobulin levels began to rise again and prednisone was reintroduced. After serum ALT levels had again fallen, the dose of prednisone was reduced and azathioprine was started (100 mg daily), ultimately allowing for discontinuation of prednisone. Serum aminotransferase levels remained normal on azathioprine alone but ANA became weakly positive. HLA typing showed A33, B42, 53 and DRB 3.

#### Key Points

Medication: | Peginterferon alfa-2a (180 µg/week)
Pattern: | Hepatocellular (R=20)
Severity: | 3+ (jaundice requiring hospitalization and intervention)
Latency: | 5 weeks to onset of jaundice
Recovery: | Incomplete, chronic autoimmune hepatitis requiring long term therapy
Other medications: | Ribavirin

#### Laboratory Values

Time After Stopping | Therapy | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | HCV RNA (IU/mL) | Other
- 8 weeks | | 204 | 91 | 0.9 | 1,420,000 | IgG 2130 mg/dL, ANA neg
- 4 weeks | | 185 | 83 | 0.7 | 2,890,000
Peginterferon (180 ug/week) started
0 | | 203 | 92 | 0.4 | 2,130,000
2 weeks | Peginterferon | 329 | 102 | 0.4 | 587,000
4 weeks | Peginterferon | 1093 | 133 | 0.9 | <100
6 weeks | Peg & Rbv | 1002 | 162 | 8.0 | <10 | IgG 2910, ANA neg, LKM pos
7 weeks | None | 1206 | 147 | 15.8 | <10
Prednisone started (20 mg daily)
8 weeks | Pred 20 mg | 1110 | 136 | 5.3 | <10
10 weeks | Pred 20 mg | 784 | 117 | 2.1 | 212,000
5 months | Pred 10 mg | 165 | 66 | 0.6
9 months | Pred 5 mg | 134 | 85 | 0.6 | 1,350,000
Prednisone stopped
18 months | None | 216 | 98 | 0.4 | 3,645,000
25 months | None | 348 | 121 | 0.8 | 2,656,800
Prednisone (20 mg daily) restarted with azathioprine
29 months | Pred 20 & Az | 54 | 100 | 0.8 | 7,452,000
40 months | Pred 5 & Az | 30 | 62 | 0.4
Prednisone stopped and azathioprine continued (100 mg daily)
4 years | Az 100 | 26 | 86 | 0.8 | 11,529,000
5 years | Az 100 | 35 | 118 | 0.5 | 20,682,000
Normal Values | | <42 | <115 | <1.2

Abbreviations: Peg, peginterferon; Rbv, ribavirin; Pred, prednisone; Az, azathioprine.

#### Comment

A patient with chronic hepatitis C and hyperglobulinemia developed worsening of serum aminotransferase levels and jaundice after 4 to 5 weeks of peginterferon therapy. Because of the autoimmune features and the lack of immediate improvement on stopping peginterferon, prednisone was started. Prednisone was gradually reduced in dose and discontinued 9 months later, but serum aminotransferase levels rose and hyperglobulinemia reappeared. Ultimately, the combination of prednisone and azathioprine led to control of the disease and normal serum aminotransferase levels. After a year of tapering doses of prednisone, it was stopped and she was maintained on azathioprine alone with normal serum aminotransferase levels despite high levels of HCV RNA. One interpretation of the events is that she had autoimmune hepatitis even before interferon therapy, and the HCV infection was benign and not the cause of the serum aminotransferase elevations. Peginterferon is known to be immunomodulatory and capable of causing an exacerbation or flare of autoimmune conditions. The presence of a serious autoimmune disease is a relative contraindication to use of interferon.

### Case 5. Autoimmune hepatitis arising during etanercept therapy.

[Modified from: Fathalla BM, Goldsmith DP, Pascasio JM, Baldridge A. Development of autoimmune hepatitis in a child with systemic-onset juvenile idiopathic arthritis during therapy with etanercept. J Clin Rheumatol 2008; 14: 297-8. PubMed Citation]

A 9 year old girl with juvenile idiopathic (rheumatoid) arthritis was treated with etanercept and hydroxychloroquine after she had failed to respond to a regimen of methotrexate, low dose prednisone and nonsteroidal antiinflammatory agents. Her dose of etanercept was increased to 50 mg weekly, which was followed by clinical improvement and allowed for lowering of the prednisone dose. Ten months after starting etanercept, she developed fatigue, abdominal discomfort and jaundice. Examination showed jaundice without fever, rash or signs of chronic liver disease. Laboratory results showed elevations in serum bilirubin (12 mg/dL) and aminotransferase levels (ALT 354 U/L, AST 486 U/L) with normal alkaline phosphatase. Tests for hepatitis A, B and C and Epstein-Barr virus were negative. Serum ANA was positive at 1:640 and SMA at 1:80, while antibodies to dsDNA and liver-kidney microsomal antigen were negative. Serum IgG levels were markedly increased (3637 mg/dL: normal <1600 mg/dL). Abdominal ultrasound was normal except for mild splenomegaly. A liver biopsy was consistent with autoimmune hepatitis with interface hepatitis and lobular necrosis with inflammation. Etanercept and hydroxychloroquine were discontinued and the dose of prednisone was increased to 2 mg/kg/day with the addition of azathioprine. Her jaundice resolved and serum aminotransferase levels fell into the normal range and autoantibodies became negative within 8 months of stopping etanercept.

#### Key Points

Medication: | Etanercept (50 mg once weekly)
Pattern: | Hepatocellular
Severity: | 3+ (jaundice, hospitalization)
Latency: | 10 months
Recovery: | Within 8 months (on prednisone)
Other medications: | Hydroxychloroquine, prednisone (5 mg daily), naproxen

#### Comment

A child with juvenile idiopathic arthritis (formerly known as juvenile rheumatoid arthritis) developed clinically apparent autoimmune hepatitis after 10 months of etanercept therapy. While it seems clear that the clinical syndrome was due to autoimmune hepatitis, it is not certain whether the hepatitis was caused by etanercept directly or was a preexisting diathesis that was triggered or merely worsened by the immunomodulatory therapy. The child improved upon stopping etanercept, but the improvement may have been due to the concurrent increase in prednisone dose and addition of azathioprine. Information on long term follow up and whether azathioprine or prednisone could be discontinued (or lowered to previous low levels) might help to resolve these issues. However, the majority of cases of autoimmune hepatitis associated with anti-TNF therapies (and other biologic agents such as the interferons) have appeared to be a triggering of autoimmune hepatitis in a susceptible patient, rather than the de novo induction of an autoimmune hepatitis-like liver injury that then resolves entirely with stopping therapy (as is typical of nitrofurantoin, minocycline or methyldopa). These different interpretations have important implications for the long term management of such patients; i.e., whether long term immune suppression will be required.

### Case 6. Autoimmune hepatitis requiring long term immunosuppression arising during atorvastatin therapy.

[Modified from: Pelli N, Setti M, Ceppa P, Toncini C, Indiveri F. Autoimmune hepatitis revealed by atorvastatin. Eur J Gastroenterol Hepatol 2003; 15: 921-4. PubMed Citation]

A 65 year old woman developed fatigue and jaundice 3 months after starting atorvastatin (20 mg daily) for long standing hypercholesterolemia. She had a history of hypertension treated with doxazosin and hypercholesterolemia treated with pravastatin for 6 months, followed by fluvastatin for 3 years before being switched to atorvastatin. She had no history of liver disease or exposures to viral hepatitis and did not drink alcohol. On examination, she was jaundiced and had hepatomegaly but no fever, rash or signs of chronic liver disease. Laboratory tests showed a hepatocellular pattern of serum enzyme elevations and mild hyperbilirubinemia (Table). Tests for viral hepatitis were negative, but she had hyperglobulinemia with IgG 6.6 g/dL (normal <1.7) and high titers of both ANA and SMA (>1:1280). A liver biopsy showed chronic hepatitis and lobular collapse and mild fibrosis. She was started on prednisone with improvement in blood tests, but three months later she still had ALT elevations and autoantibody titers had not declined. A repeat liver biopsy showed early cirrhosis.

#### Key Points

Medication: | Atorvastatin (20 mg daily)
Pattern: | Hepatocellular (R=7.5)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 3 months
Recovery: | Incomplete
Other medications: | Doxazosin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P (U/L) | Bilirubin* (mg/dL) | Other
12 weeks | 0 | 510 | 481 | 3.0 | Prothrombin index 17%
13 weeks | 1 week | 430 | | 2.5 | ANA >1:1280
14 weeks | 2 weeks | 280 | | 4.4 | First liver biopsy
15 weeks | 3 weeks | 220 | | 5.6
16 weeks | 4 weeks | 305 | | 4.3 | Prednisone started
18 weeks | 6 weeks | 210 | | 2.6
19 weeks | 7 weeks | 105 | | 2.4
5 months | 3 months | 80 | | 1.5 | ANA >1:1280
6 months | 4 months | 66 | 66 | 1.1 | Second liver biopsy
Normal Values | | <40 | <279 | <1.2

* Values estimated from Figure 3. Bilirubin converted from µmol to mg/dL.

#### Comment

Jaundice and features of autoimmune hepatitis arose after 3 months of atorvastatin therapy in a patient who had been treated with other statins for more than 3 years. Liver tests improved minimally with stopping atorvastatin and one month later prednisone was started, whereupon serum enzymes decreased from ~8 fold to ~twice normal. However, serum autoantibodies remained present in unchanging titers, and a repeat liver biopsy showed progression of fibrosis with nodularity and incomplete cirrhosis. In this case, atorvastatin appeared to trigger a self sustained autoimmune hepatitis. An alternative explanation is that atorvastatin was an innocent bystander and the development of autoimmune hepatitis was co-incidental and unrelated to the chronic statin therapy.

## Selected References

Goldstein GB, Lam KC, Mistilis SP. (1973). Drug-induced active chronic hepatitis. Am J Dig Dis. (Among 21 cases of "active chronic hepatitis" presenting over a 1 year period, 9 were due to oxyphenisatin, 5 to methyldopa and 9 were idiopathic; methyldopa cases were all jaundiced and AST 200-600 U/L, latency averaged 15 months, all responded to corticosteroids; no mention of ANA).
Toghill PJ, Smith PG, Benton P, Brown RC, Matthews HL. (1974). Methyldopa liver damage. Br Med J. (Characterization of 20 cases of methyldopa induced liver injury: latency 2-32 weeks, most <6 weeks, all jaundiced, mostly hepatocellular or mixed, but two cholestatic, resolved with stopping; 2 chronic active hepatitis, 2 acute liver failure, 2 cirrhosis, severe recurrence with reexposure).
Neuberger J, Kenna JG, Nouri Aria K, Williams R. (1985). Antibody mediated hepatocyte injury in methyl dopa induced hepatotoxicity. Gut. (9 cases of methyldopa hepatotoxicity: 5 with acute liver failure, 3 acute self limited hepatitis, 1 chronic active hepatitis; injury arose 7 weeks to 3 years after starting methyldopa).
Stricker BH, Blok AP, Claas FH, Van Parys GE. (1988). Desmet VJl. Hepatic injury associated with the use of nitrofurans: a clinicopathological study of 52 reported cases. Hepatology. (Analysis of 52 cases reported to a Central Registry in the Netherlands, 27 of which were considered at least "probable"; onset varied from less than a week to several years after starting nitrofurantoin; overall, 59% were jaundiced, 11% had rash and 20% eosinophilia, 2 were fatal, estimated to occur in 1:3000-1:5000 users; separated cases into "acute" vs "chronic" injury, chronic cases more likely to have ANA positivity and hepatocellular pattern of injury).
Adams LE, Hess EV. (1991). Drug-related lupus. Incidence, mechanisms and clinical implications. Drug Saf. (Review of drug related lupus-like syndrome, linked to more than 60 agents including isoniazid, hydralazine, chlorpromazine, methyldopa and procainamide; usually presents with arthralgias and fever and ANA positivity, usually occurring with long term use of the medication).
Papo T, Marcellin P, Bernuau J, Durand F, Poynard T, Benhamou JP. (1992). Autoimmune chronic hepatitis exacerbated by alpha-interferon. Ann Intern Med. (3 patients, one man and two women, 20, 40 and 42 years old, with autoimmune hepatitis [misdiagnosed initially as hepatitis C] had flares of hepatitis on interferon with onset of symptoms after 8, 4 and 4 weeks of treatment [bilirubin 15.5 mg/dL in one, but evidently normal in the others with peak ALT 1728, 378 and 456 U/L, autoantibodies present], improving with stopping interferon and adding prednisone; all 3 were anti-HCV negative by sensitive and specific assays).
Ganne-Carrié N, de Leusse A, Guettier C, Castera L, Levecq H, Bertrand HJ, Plumet Y, et al. (1998). Gastroenterol Clin Biol. (Retrospective analysis of 5 patients [4 men, 1 woman] with chronic hepatitis due to fibrates identified between 1989-1996; ages 56-73 years, on fenofibrate [n=3] or ciprofibrate [n=2] for 5-36 months; 2 asymptomatic; none with immunoallergic features or eosinophilia, with bilirubin 0.6-36 mg/dL, ALT 4-26 times ULN; all had ANA 1:200-1:2560; liver biopsy showed active cirrhosis in 3 and chronic hepatitis with fibrosis in 2; hepatitis resolved spontaneously in 2 and 3 required corticosteroid therapy, in 2 of whom they could be stopped without relapse).
Elkayam O, Yaron M, Caspi D. (1999). Minocycline-induced autoimmune syndromes: an overview. Semin Arthritis Rheum. (Systematic review of literature on autoimmune syndromes from minocycline, 4 patterns: serum sickness, lupus-like syndrome, autoimmune hepatitis and vasculitis; usually presenting after 1-20 years, ANA common but so is pANCA, features may overlap, hepatitis most common: 66 cases reported).
Goldstein NS, Bayati N, Silverman AL, Gordon SC. (2000). Minocycline as a cause of drug-induced autoimmune hepatitis. Report of four cases and comparison with autoimmune hepatitis. Am J Clin Pathol. (Four cases of minocycline hepatitis and comparison to 10 spontaneous autoimmune hepatitis cases showed no distinguishing features except resolution with stopping drug; 16-52 year old women developed liver injury 4 months to 12 years after starting minocycline [bilirubin 0.4, 1.2, 6.5 and 7.3 mg/dL, ALT 137, 343, 700, and 1288 U/L, Alk P 49, 83, 138 and 253 U/L, all ANA positive], histology showed fibrosis in 2, all responded to prednisone with resolution persisting after stopping corticosteroids).
Alla V, Abraham J, Siddiqui J, Raina D, Wu GY, Chalasani NP, Bonkovsky HL. (2006). Autoimmune hepatitis triggered by statins. J Clin Gastroenterol. (Three cases of autoimmune hepatitis arising after simvastatin or atorvastatin therapy 6, 20 and 20 weeks after starting [bilirubin 11.3, 3.4 and 5.5 mg/dL, ALT 1749, 1170 and 155 U/L, Alk P of 228, 160, and 203 U/L, all being ANA or SMA positive in titers of 1:40 to 1:160], all responding to prednisone/azathioprine but remaining on long term therapy with azathioprine or mycophenylate alone).
Behrbolm J, Neid M, Stolzel U, Wittekind C, Hauss JP, Tillmann HL. (2007). Improvement of multiple sclerosis on tacrolimus plus mycophenolate mofetil after liver transplantation. Transplant Int. (51 year old woman with multiple sclerosis developed jaundice 8 weeks after starting interferon beta [36.9 mg/dL, INR 1.7, ANA 1:160], progressing to liver failure and transplantation 3 days later; explant histology suggested autoimmune hepatitis).
Fathalla BM, Goldsmith DP, Pascasio JM, Baldridge A. (2008). Development of autoimmune hepatitis in a child with systemic-onset juvenile idiopathic arthritis during therapy with etanercept. J Clin Rheumatol. (9 year old girl with juvenile idiopathic [rheumatoid] arthritis developed abdominal pain and jaundice 10 months after starting etanercept [bilirubin 12.0 mg/dL, ALT 354 U/L, GGT 388 U/L, ANA 1:640, IgG 3637 mg/dL], stopping etanercept and starting prednisone and azathioprine led to resolution, normal liver tests and negative ANA: Case 5).
Goujon C, Dahel K, Bérd F, Guillot I, Gunera-Saad N, Nicolas JF. (2010). Autoimmune hepatitis in two psoriasis patients treated with infliximab. J Am Acad Dermatol. (Two cases of autoimmune hepatitis during infliximab therapy, 37 and 51 year old men with psoriasis developed symptoms 4-6 weeks after a third infusion [bilirubin 0.8 and 3.2 mg/dL, ALT 1126 and 768 U/L, Alk P 181 and 391 U/L, ANA 1:200 and 1:2560], one resolving upon stopping and one after treatment with ursodiol, corticosteroids and azathioprine).
Björnsson E, Talwalkar J, Treeprasertsuk S, Kamath PS, Takahashi N, Sanderson S, Neuhauser M, Lindor K. (2010). Drug-induced autoimmune hepatitis: clinical characteristics and prognosis. Hepatology. (Among 261 cases of autoimmune hepatitis seen at the Mayo Clinic between 1997 and 2007, 24 were attributed to drugs, 11 to minocylcine, 11 to nitrofurantoin and 2 to others; all responded to corticosteroid therapy and all who were withdrawn did not relapse).
Czaja AJ. (2011). Drug-induced autoimmune-like hepatitis. Dig Dis Sci. (Review of drug induced autoimmune hepatitis-like syndromes, most commonly caused by nitrofurantoin and minocycline, but also with hydralazine, methyldopa and more rarely with statins, fibrates, NSAIDs, various herbals and tumor necrosis factor antagonists).

## Hepatic Histology in Autoimmune Hepatitis

[Under Construction]